# Regorafenib

## OVERVIEW

### Introduction

Regorafenib is an oral multi-kinase inhibitor that is used in the therapy of refractory metastatic colorectal cancer, hepatocellular carcinoma and gastrointestinal stromal tumor. Regorafenib has been associated with frequent serum aminotransferase elevations during therapy and with rare, but sometimes severe and even fatal instances of clinically apparent liver injury.

### Background

Regorafenib (re goe raf’ e nib) is an orally available, small molecule, multi-specific kinase inhibitor with activity against vascular endothelial growth factors (VEGF) receptors -1, -2 and -3, as well as against the receptor for platelet derived growth factor (PDGF) and several RAF kinases, c-Kit and TIE2. Inhibition of these kinases decreases angiogenesis, which plays an important role in the growth and spread of several forms of solid tumors. Regorafenib received approval for use in the United States in 2012 for therapy of metastatic colorectal cancer and advanced, unresectable gastrointestinal stromal tumors after failure of other antineoplastic agents. Indications were extended in 2017 to include refractory hepatocellular carcinoma. Regorafenib is available in tablets of 40 mg under the brand name Stivarga. The typical dose is 160 mg once daily for 21 days in 28 day cycles continued until there is tumor progression or unacceptable toxicity. Side effects are common and can include fatigue, diarrhea, anorexia, weight loss, nausea, abdominal pain, hand-foot syndrome, hypertension, mucositis, dysphonia, infections, rash and fever. Uncommon, but potentially severe side effects include bleeding, poor wound healing, gastrointestinal perforation and fistula, hypertension, severe skin toxicities, cardiac ischemia and reversible posterior leukoencephalopathy syndrome.

### Hepatotoxicity

In large clinical trials of regorafenib, elevations in serum aminotransferase levels were common, occurring in 39% to 45% of patients, and were greater than 5 times the upper limit of normal (ULN) in 3% to 6%. In addition, there have been several reports of clinically apparent liver injury arising during regorafenib therapy which was often severe and occasionally fatal, estimated to occur in 0.3% of treated subjects. For these reasons, routine monitoring of liver enzymes is recommended. Regorafenib induced liver injury can present in several different patterns or phenotypes. Some patients present within a few days of starting regorafenib with acute hepatic necrosis, high levels of serum aminotransferase and lactic dehydrogenase with mild jaundice, but prolongation of INR and signs of hepatic failure. The injury can be severe but is generally self-limited and recovery is rapid and complete. Other patients present with an acute viral hepatitis like pattern, hepatocelllar (or mixed) serum enzyme elevations and jaundice that can be prolonged and has been fatal in several instances. Autoimmune and immunoallergic features are uncommon. In addition, rare instances of regorafenib associated liver injury have presented with a sinusoidal obstruction-like syndrome or pseudocirrhosis, with marked hepatic nodularity and ascites that eventually improves or resolves. Finally, regorafenib, like other multi-kinase inhibitors [sunitinib, imatinib, sorafenib], has also been associated with episodes of hyperammonemic coma generally arising within a few days or weeks of starting and with rapid reversal upon stopping treatment.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum enzyme elevations and liver injury during regorafenib therapy is not known. Regorafenib is metabolized in the liver largely through the CYP 3A4 pathway and liver injury may be related to production of a toxic intermediate. Because regorafenib inhibits multiple kinases, it may interfere with normal hepatocyte pathways involved in cell metabolism, injury and repair making the cell injury multifactorial. In addition, because regorafenib is metabolized by CYP 3A4, it is susceptible to drug-drug interactions with agents that inhibit or induce this hepatic microsomal enzyme.

### Outcome and Management

Routine monitoring of liver tests before and every two weeks during the first 2 months of treatment as well as regularly thereafter is recommended for patients receiving regorafenib. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to at least temporary cessation, and elevations accompanied by jaundice or symptoms to permanent discontinuation. It is not clear whether such monitoring is effective in preventing regorafenib liver injury, but early discontinuation is likely to be helpful in limiting the severity and consequences of the injury. Regorafenib has been implicated in cases of acute liver failure, but not in instances of chronic hepatitis or vanishing bile duct syndrome. There does not appear to be cross reactivity in risk for hepatic injury between regorafenib and other multi-kinase inhibitors such axitinib, sorafenib and sunitinib, but caution and careful monitoring should be used in regarding a kinase inhibitor after clinically apparent liver injury from regorafenib.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## CASE REPORTS

### Case 1. Pseudocirrhosis due to regorafenib.

[Modified from a case in the database of the Drug-Induced Liver Injury Network]

A 58 year old man with advanced and refractory leiomyosarcoma with metastases to the liver, lungs and bones was placed on an experimental protocol with regorafenib. Within a week of starting the multikinase inhibitor he developed fatigue, nausea, abdominal pain, dark urine and jaundice. Serum enzyme levels were elevated before starting treatment and had increased minimally but bilirubin rose precipitously from 0.6 to 5.3 mg/dL. He had no previous history of liver disease, alcohol abuse or risk factors for viral hepatitis. His other medical conditions included anxiety, insomnia, hypothyroidism and essential hypertension. Regorafenib was stopped and he was followed as an outpatient but admitted one week later when bilirubin had risen to 9.3 mg/dL, prothrombin time increased to 1.3 and peripheral enema, anasarca and ascites developed. He had a prolonged hospital stay with diuretic therapy, paracentesis for ascites, opiates for pain and further investigations that identified brain metastases. Tests for hepatitis A, B, C and E were negative as were autoantibodies. Imaging of the liver showed the previously noted liver metastases but no evidence of biliary obstruction. After several months, jaundice and ascites began to improve. He was discharged to hospice care and died approximately 5 months after onset of jaundice.

#### Key Points

Medication: | Regorafenib 160 mg daily for 7 days
Pattern: | Cholestatic (R=0.9)
Severity: | 4+ (jaundice, coagulopathy, ascites)
Latency: | 7 days
Recovery: | Partial recovery 3 months
Other medications: | amlodipine, lisinopril, hydrochlorothiazide, labetalol, levothyroxine, alprazolam, diazepam, ondansetron, oxycodone,

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
-35 days | Pre | 37 | 136 | 0.9
-21 days | Pre | 82 | 221 | 0.7
-14 days | Pre | 63 | 168 | 0.6
-7 days | Pre | 105 | 247 | 0.4
0 | Pre | 141 | 282 | 0.6 | Regorafenib started
1 week | 0 | 149 | 297 | 5.3 | Regorafenib stopped
2 weeks | 8 days | 135 | 484 | 9.3 | Ultrasound, INR 1.3
| 15 days | 133 | 414 | 12.1 | Ascites, albumin 2.8
| 20 days | 152 | 573 | 12.4 | INR 1.5
| 35 days | 84 | 326 | 12.1 | INR 1.7, albumin 2.3
| 2 months | 53 | 541 | 11.4
| 3 months | 44 | 708 | 3.8
| 4 months | 28 | 488 | 1.7
Normal Values | | <35 | <125 | <1.2

#### Comment

A dramatic onset of jaundice within a week of starting regorafenib for metastatic leiomyosarcoma that was rapidly followed by ascites and anasarca. This rapid presentation of what seems to be decompensated cirrhosis is typical of "pseudocirrhosis" complicating high potent targeted anticancer therapy in patients with hepatic metastases. Most evidence suggests that the syndrome is due to rapid shrinkage of tumor resulting in a nodular, somewhat atrophic liver with hepatic synthetic failure and portal hypertension. The majority of patients improve or appear to recover completely, although progress of the metastatic liver disease frequently results in mortality soon after the onset of liver disease. Other interpretations of this course of injury are progression of the metastatic disease and possibly another form of superimposed drug induced liver injury (from labetolol for instance). Neither of these possibilities appear likely. The lack of evidence of biliary obstruction and the eventual resolution of the jaundice and ascites are not well explained by these other possibilities.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Regorafenib – Stivarga®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Regorafenib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Regorafenib | 755037-03-7 | C21-H15-Cl-F4-N4-O3 | Regorafenib chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2018

Abbreviations: GIST, gastrointestinal stromal tumor; HCC, hepatocellular carcinoma.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors such as regorafenib).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-67. (Review of hepatotoxicity of cancer chemotherapeutic agents; imatinib, gefitinib, erlotinib and crizotinib are discussed, but not regorafenib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Eisen T, Joensuu H, Nathan PD, Harper PG, Wojtukiewicz MZ, Nicholson S, Bahl A, et al. Regorafenib for patients with previously untreated metastatic or unresectable renal-cell carcinoma: a single-group phase 2 trial. Lancet Oncol 2012; 13: 1055-62. (Among 49 patients with metastatic or unresectable renal cell cancer treated with regorafenib for 1-34 months, 40% had a partial response and side effects were common [98%], often severe [71%] and occasionally fatal [4%]; no mention of ALT elevations or hepatotoxicity). 22959186
George S, Wang Q, Heinrich MC, Corless CL, Zhu M, Butrynski JE, Morgan JA, et al. Efficacy and safety of regorafenib in patients with metastatic and/or unresectable GI stromal tumor after failure of imatinib and sunitinib: a multicenter phase II trial. J Clin Oncol 2012; 30: 2401-7. (Among 34 patients with GIST and progression despite imatinib and sunitinib therapy, 4 had a partial response to regorafenib and common side effects were hand-foot syndrome [85%], fatigue [79%], hypertension [67%], diarrhea [61%] and hoarseness [46%]; no mention of ALT elevations or hepatotoxicity). 22614970
Demetri GD, Reichardt P, Kang YK, Blay JY, Rutkowski P, Gelderblom H, Hohenberger P, et al.; GRID study investigators. Efficacy and safety of regorafenib for advanced gastrointestinal stromal tumours after failure of imatinib and sunitinib (GRID): an international, multicentre, randomised, placebo-controlled, phase 3 trial. Lancet 2013; 381(9863): 295-302. (Among 199 patients with advanced GIST after failure of other kinase inhibitors, regorafenib therapy yielded a longer progression free survival [4.8 months] compared to placebo [0.8 months], but no change in overall survival; side effects were common [98%] and often severe [60%]; no mention of ALT elevations or hepatotoxicity). 23177515
Grothey A, Van Cutsem E, Sobrero A, Siena S, Falcone A, Ychou M, Humblet Y, et al.; CORRECT Study Group. Regorafenib monotherapy for previously treated metastatic colorectal cancer (CORRECT): an international, multicentre, randomised, placebo-controlled, phase 3 trial. Lancet 2013; 381 (9863): 303-12. (Among 760 patients with metastatic colorectal cancer, overall median survival was 6.4 months with regorafenib therapy vs 5.0 months with placebo, and side effects were frequent [93%] and often severe [55%]; no mention of ALT elevations or hepatotoxicity). 23177514
Waddell T, Cunningham D. Evaluation of regorafenib in colorectal cancer and GIST. Lancet 2013; 381 (9863): 273-5. (Editorial accompanying clinical trials of Demetri [2013] and Grothey [2013] mentions that the clinical benefits were modest, but that "the case for routine use of regorafenib ... is strong, despite the apparent absence of a benefit in terms of overall survival"). 23177516
Regorafenib (Stivarga) for metastatic colorectal cancer and GIST. Med Lett Drugs Ther 2013; 55 (1415): e36. (Concise review of the efficacy, safety and costs of regorafenib in colorectal cancer and GIST shortly after its approval for this use in the US, mentions that regorafenib can cause severe liver injury). 23836345
Bruix J, Tak WY, Gasbarrini A, Santoro A, Colombo M, Lim HY, Mazzaferro V, et al. Regorafenib as second-line therapy for intermediate or advanced hepatocellular carcinoma: multicentre, open-label, phase II safety study. Eur J Cancer 2013; 49: 3412-9. (Among 36 patients with advanced hepatocellular carcinoma who were treated for 2-103 weeks with regorafenib, 3% had a partial response and 69% had stable disease with a median survival of 13.8 months; side effects were common [97%], often severe [58%], and 2 patients died of hepatic failure, but the complication was judged to be unrelated to therapy). 23809766
Shah RR, Morganroth J, Shah DR. Hepatotoxicity of tyrosine kinase inhibitors: clinical and regulatory perspectives. Drug Saf 2013; 36: 491-503. (Review of the hepatotoxicity of 18 tyrosine kinase inhibitors approved for use in cancer in the US as of 2013; regorafenib therapy is accompanied by ALT or AST elevations in 45-65% of patients [above 5 times ULN in 6%] generally during the first 2-6 weeks of therapy, and linked to rare cases of clinically apparent hepatitis and to instances of hepatic failure and death). 23620168
Iacovelli R, Palazzo A, Procopio G, Santoni M, Trenta P, De Benedetto A, Mezi S, et al. Incidence and relative risk of hepatic toxicity in patients treated with anti-angiogenic tyrosine kinase inhibitors for malignancy. Br J Clin Pharmacol 2014; 77: 929-38. (Systematic review of liver toxicity reported in controlled trials of kinase inhibitors used to treat solid tumors identified 6 articles with 3691 patients, among whom 34% had ALT elevations with kinase inhibitor therapy compared to 24% of controls [above 5 times ULN in 5.2% vs 1.4%], with highest rates for sorafenib and pazopanib). 23981115
Kuo JC, Parakh S, Yip D. Regorafenib-induced hyperammonemic encephalopathy. J Clin Pharm Ther 2014; 39: 446-8. (61 year old man with metastatic GIST with liver involvement developed confusion 13 months after starting regorafenib that resolved rapidly with stopping and recurred rapidly on restarting regorafenib [ammonia 105 μmol/L], resolving within 4 days of stopping again). 24707992
De Wit M, Boers-Doets CB, Saettini A, Vermeersch K, de Juan CR, Ouwerkerk J, Raynard SS, et al. Prevention and management of adverse events related to regorafenib. Support Care Cancer 2014; 22 (3): 837-46. (Summary recommendations for management of common side effects of regorafenib including liver test abnormalities). 24337717
Li J, Qin S, Xu R, Yau TC, Ma B, Pan H, Xu J, et al; CONCUR Investigators. Regorafenib plus best supportive care versus placebo plus best supportive care in Asian patients with previously treated metastatic colorectal cancer (CONCUR): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet Oncol 2015; 16: 619-29. (Among 204 Asian patients with refractory, metastatic colorectal cancer treated with regorafenib or placebo, median overall survival was better with regorafenib [8.8 vs 6.3 months], but severe adverse events were more frequent [9% vs 4%], as were hand-foot-skin reaction [16% vs none] and ALT elevations [24% vs 7%] which were above 5 times ULN in 7% vs 0%). 25981818
Karczmarek-Borowska B, Sałek-Zań A. Hepatotoxicity of molecular targeted therapy. Contemp Oncol (Pozn) 2015; 19: 87-92. (Review of hepatotoxicity of modern molecular targeted therapies including monoclonal antibodies, protein kinase inhibitors and proteosome inhibitors; regorafenib has an increased risk of liver injury). 26034384
Akamine T, Ando K, Oki E, Saeki H, Nakashima Y, Imamura YU, Ohgaki K, et al. Acute liver failure due to regorafenib may be caused by impaired liver blood flow: a case report. Anticancer Res 2015; 35: 4037-41. (50 year old Japanese woman with metastatic GIST developed fatigue, fever and seizures 10 days after starting regorafenib [bilirubin 1.6 rising to 4.5 mg/dL, ALT 100 to ~600 U/L, Alk P not given], with rapid resolution and normal values 14 days later). 26124352
Raissouni S, Quraishi Z, Al-Ghamdi M, Monzon J, Tang P, Vickers MM. Acute liver failure and seizures as a consequence of regorafenib exposure in advanced rectal cancer. BMC Res Notes 2015; 8: 538. (64 year old woman with metastatic colon cancer developed diarrhea and jaundice 5 days after starting regorafenib [bilirubin 4.8 mg/dL, ALT 1290 U/L, Alk P 267 U/L, INR 2.6], resolving rapidly upon stopping with normal liver tests 14 days later). 26438070
Kuwayama M, Uchino K, Takayoshi K, Komoda M, Kohjima M, Nakamuta M, Momosaki S, et al. Immunosuppressant therapy successfully improved regorafenib-induced severe hepatic injury in a patient with metastatic gastrointestinal stromal tumor: A case report. Oncol Lett 2016; 11: 85-8. (75 year old man with GIST developed fever followed by abnormal liver tests 28 days after starting regorafenib [bilirubin 1.1 rising to 5.2 mg/dL, ALT 274 to 2534 U/L, Alk P not given], with rapid improvement on stopping and with use of prednisone). 26870172
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5%] were attributed to antineoplastic agents including one case due to regorafenib). 25754159
Takahashi M, Harada S, Suzuki H, Yamashita N, Orita H, Kato M, Kotoh K. Regorafenib could cause sinusoidal obstruction syndrome. J Gastrointest Oncol 2016; 7: E41-4. (74 year old Japanese man with colorectal cancer developed diarrhea 2 weeks and liver test abnormalities with ascites 4 weeks after starting regorafenib [bilirubin 2.3 mg/dL, ALT 978 U/L, Alk P 673 U/L, INR 1.5], which resolved rapidly with plasma exchange and corticosteroid therapy). 27284487
Adenis A, de la Fouchardiere C, Paule B, Burtin P, Tougeron D, Wallet J, Dourthe LM, et al. Survival, safety, and prognostic factors for outcome with Regorafenib in patients with metastatic colorectal cancer refractory to standard therapies: results from a multicenter study (REBECCA) nested within a compassionate use program. BMC Cancer 2016; 16: 412. (Among 1178 patients with metastatic colorectal cancer treated with regorafenib, the 12 months survival rate was 22% and adverse event rate 80%; no specific mention of ALT elevations or hepatotoxicity). 27389564
Sacré A, Lanthier N, Dano H, Aydin S, Leggenhager D, Weber A, Dekairelle AF, et al. Regorafenib induced severe toxic hepatitis: characterization and discussion. Liver Int 2016; 36: 1590-4. (Among 93 Belgian patients with metastatic colorectal cancer treated with regorafenib, 2 women and 1 man, ages 66 to 68 years developed "severe toxic hepatitis" between 2 weeks and 4 months of starting [bilirubin 8.4, 19.0 and 5.2 mg/dL, ALT 3209, 3268 and 1738 U/L, Alk P 234, 294 and 296 U/L], 1 dying within 5 weeks of acute liver failure and the other two dying 6 and 10 months later due to the underlying malignancy). 27500989
Mir O, Brodowicz T, Italiano A, Wallet J, Blay JY, Bertucci F, Chevreau C, et al. Safety and efficacy of regorafenib in patients with advanced soft tissue sarcoma (REGOSARC): a randomised, double-blind, placebo-controlled, phase 2 trial. Lancet Oncol 2016; 17: 1732-42. (Among 182 patients with refractory advanced soft tissue sarcoma treated with regorafenib vs placebo, progression free survival was improved in several non-adipocyte forms of sarcoma while adverse events were frequent, ALT or AST elevations arising in 10% vs 3%, and one regorafenib treated subject died of hepatic failure). 27751846
Bruix J, Qin S, Merle P, Granito A, Huang YH, Bodoky G, Pracht M, et al; RESORCE Investigators. Regorafenib for patients with hepatocellular carcinoma who progressed on sorafenib treatment (RESORCE): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet 2017; 389: 56-66. (Among 573 patients with refractory, advanced HCC treated with regorafenib or placebo, the median overall survival was improved with regorafenib [10.6 vs 7.8 months] and adverse events were common in both groups, ALT elevations occurring in 15% vs 11% and rising to above 5 times ULN in 4% vs 3%, with 2 deaths from liver failure in the placebo group). 27932229
Kumamoto K, Endo S, Isohata N, Nirei A, Nemoto D, Utano K, Saito T, et al. Pseudocirrhosis caused by regorafenib in an advanced rectal cancer patient with multiple liver metastases. Mol Clin Oncol 2017; 6: 63-6. (70 year old man with advanced, refractory colorectal cancer developed abdominal distress and ascites 3 weeks after starting regorafenib [bilirubin 0.6 mg/dL, ALT 40 U/L, Alk P 505 U/L, albumin 1.8 g/dL], with atrophic appearing liver and shrinkage of metastasis, resolving within 1 month, a pattern suggestive of pseudocirrhosis). 28123730
Maeda A, Ando H, Ura T, Komori A, Hasegawa A, Taniguchi H, Kadowaki S, et al. Association between ABCG2 and SLCO1B1 polymorphisms and adverse drug reactions to regorafenib: a preliminary study . Int J Clin Pharmacol Ther 2017; 55: 409-15. (Among 37 Japanese adults with cancer treated with regorafenib, adverse events and elevations in ALT [4%], AST [8%] and bilirubin [12%] had little relationship with presence of genetic variants of ABCG2 and SLCO1B1). 28157071
Quirino M, Rossi S, Schinzari G, Basso M, Strippoli A, Cassano A, Barone C. Unexpected side effect in mCRC: A care-compliant case report of regorafenib-induced hyperammonemic encephalopathy. Medicine (Baltimore) 2017; 96: e6522. (56 year old man with metastatic colorectal cancer developed confusion 2 days after starting regorafenib [bilirubin and serum enzymes normal, ammonia 191 mmol/L], resolving within a few days of stopping and recurring 7 days after restarting regorafenib at a lower dose). 28422839
Béchade D, Desjardin M, Castain C, Bernard PH, Fonck M. Fatal acute liver failure as a consequence of regorafenib treatment in a metastatic colon cancer. Case Rep Oncol 2017; 10: 790-4. (65 year old French woman with refractor colorectal cancer developed jaundice, diarrhea and fever 8 weeks after starting regorafenib [bilirubin 19.4 mg/dL, ALT 1620 U/L, Alk P 188 U/L, factor V 65%], with progressive liver failure and death 10 days after presentation). 28966584
Uetake H, Sugihara K, Muro K, Sunaya T, Horiuchi-Yamamoto Y, Takikawa H. Clinical Features of regorafenib-induced liver injury in Japanese patients from postmarketing experience. Clin Colorectal Cancer 2018; 17: e49-e58. (In safety analyses of postmarketing databases and spontaneous adverse event reports, ALT or AST elevatitons above 5 times ULN occurred in 11.8% and ALT elevations with jaundice in 1.3% of regorafenib treated patients, with death from liver failure in 27 of 8380 exposed subjects [0.3%]). 29074353
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Review of the hepatotoxicity of recently approved medications including the antineoplastic tyrosine kinase inhibitors such as imatinib, bosutinib, ponatinib, nilotinib, gefitinib, erlotinib, crizotinib, lapatinib, sunitinib, pazopanib, vemurafenib and regorafenib). 27842767

## OTHER REFERENCE LINKS

1. Recent References on Regorafenib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Regorafenib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Regorafenib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Regorafenib)